# Chi R Yun

## OVERVIEW

### Introduction

Chi R Yun is the Chinese proprietary name for extracts of Breynia officinalis, which has been used as an herbal medication alone and in combination with other botanicals to treat a variety of conditions including heart failure, venereal disease, growth retardation, contusions and conjunctivitis. Taken in higher than recommended doses, breynia is considered a poison and can cause gastrointestinal, hepatic, urinary and respiratory injury.

### Background

Breynia officinalis is a species of Euphorbiaceae, which is known by the Chinese name of “Chi R Yun” which means “7 days of dizziness.” It is used frequently in combination with other herbs in low doses to treat venereal disease, contusions, heart failure, growth retardation and conjunctivitis. In higher doses, it is considered a poison and results in neurological, gastrointestinal, urinary and respiratory toxicity.

### Hepatotoxicity

Breynia overdose or poisoning causes diarrhea, nausea, fever, abdominal discomfort, palpitations, dry mouth and vertigo. Liver tests are also commonly abnormal in a dose related manner, with prominent elevations in serum aminotransferase levels and either no or minor increases in bilirubin and alkaline phosphatase levels. The liver injury is usually overshadowed by gastrointestinal symptoms, although laboratory abnormalities may persist longer than clinical symptoms for up to 1 to 2 months. Other systemic symptoms and complications that are usually present include dizziness, headache, lethargy, numbness, muscle weakness, respiratory symptoms, cough, hemoptysis, hematuria and bloody stools. The symptoms and liver test abnormalities generally resolve within 4 to 6 weeks of the exposure. Most reports have been from Asia and none since the early years of the 21^st^ century.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The toxic components of Breynia include several phytotoxins and the liver injury appears to be a direct hepatotoxicity.

### Outcome and Management

Hepatotoxicity from Breynia officinalis is usually self-limiting and should be managed with supportive care.

Drug Class: Herbal and Dietary Supplements; Chinese and Other Asian Herbal Medicines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Chi R Yun – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Chi R Yun | Not Available | Herbal mixture | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 24 May 2022

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; hepatotoxicity of Asian herbal products and teas are discussed generally without focus on any specific product or herb).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbs and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; Chinese and other Asian herbal medicines and teas are discussed, including Breynia).
Stedman C. (2002). Herbal hepatotoxicity. Semin Liver Dis. (Review and description of patterns of herbal-induced liver injury, including discussion of potential risk factors, and herb-drug interactions).
Ernst E. (2002). Adulteration of Chinese herbal medicines with synthetic drugs: a systematic review. J Intern Med. (Systematic review of literature on adulteration of herbals with conventional medications, in 15 case reports and 2 cases series of 21 patients; included NSAIDs, corticosteroids, benzodiazepines, diuretics and antidiabetic medications, in up to 24% of products).
Lin TJ, Tsai MS, Chiou NM, Deng JF, Chiu NY. (2002). Hepatotoxicity caused by Breynia officinalis. Vet Hum Toxicol. (Two women ages 43 and 51 years took large amounts of Breynia [one in suicide attempt] and rapidly developed vertigo, vomiting, headache and numbness [peak bilirubin 2.2 and 1.0 mg/dL, ALT 2443 and 2730 U/L, Alk P 103 and 107 U/L], resolving over the next 4 to 6 weeks).
Lin TJ, Su CC, Lan CK, Jiang DD, Tsai JL, Tsai MS. (2003). Acute poisonings with Breynia officinalis—an outbreak of hepatotoxicity. J Toxicol Clin Toxicol. (Breynia officinalis is used in many Chinese medicines, but it also contains a poison and the plant can be mistaken for other herbs; 19 Chinese villagers drank a soup made from Breynia and developed diarrhea, nausea and liver test abnormalities [peak bilirubin 1.5-2.6, ALT 65-7398 U/L, Alk P 269 U/L], returning to normal in 1-2 months).
Wai CT, Tan BH, Chan CL, Sutedja DS, Lee YM, Khor C, Lim SG. (2007). Drug-induced liver injury at an Asian center: a prospective study. Liver Int. (Prospective survey of drug induced liver injury presenting over 26 months at a single hospital in Singapore identified 31 cases, ages 18-90 years, 55% male, Chinese traditional medicines being implicated in 17 [55%] and Malay agents in 5 cases [16%], adulterants were found in 9 of 31 tested traditional agents [codeine, corticosteroids, metformin, mercury, nonsteroidal antiinflammatory agents]).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Liver injury induced by “natural remedies”: an analysis of cases submitted to the Spanish Liver Toxicity Registry. Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, none attributed to Breynia).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications; Breynia not listed).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS including traditional Chinese herbal medicines; breynia not discussed).
Wang YP, Shi B, Chen YX, Xu J, Jiang CF, Xie WF. (2009). Drug-induced liver disease: an 8-year study of patients from one gastroenterological department. J Dig Dis. (30 patients with drug induced liver disease seen at a single medical university in Shanghai between 2000 and 2008, of which 12 were attributed to Chinese herbs, but specific agents not discussed, 9 were jaundiced, 6 hepatocellular, 3 cholestatic and 2 mixed).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (Systematic tabulation of the literature on hepatotoxicity of herbals does not list or discuss Chi R Yun or Breynia).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Review of HDS associated hepatotoxicity does not discuss Chi R Yun or Breynia officinalis).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury enrolled in a US prospective study between 2004 and 2013, neither Chi R Yun nor Breynia officinalis were implicated in any).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a U.S. prospective database between 2004 and 2012, HDS were implicated in 145 [16%] cases, but none were attributed to Chi R Yun or Breynia officinalis).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of herbal associated liver injury does not discuss Chi R Yun or Breynia officinalis).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not mention Chi R Yun or Breynia officinalis).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], while none were attributed to Chi R Yun or Breynia officinalis).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2021:S1542-3565(21)00013-6. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while none were attributed to Chi R Yun or Breynia officinalis).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava [62 and greater celandine [48]; but none were attributed to Chi R Yun or Breynia officinalis).

## OTHER REFERENCE LINKS

1 Recent References on Chi R Yun: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Chi+R+Yun+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Chi R Yun: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Chi+R+Yun)